# Felodipine

## OVERVIEW

### Introduction

Felodipine is a second generation calcium channel blocker and commonly used antihypertensive agent. Felodipine therapy has been associated with a low rate of serum enzyme elevations, but has not been convincingly linked to instances of clinically apparent, acute liver injury.

### Background

Felodipine (fe loe' di peen) belongs to the dihydropyridine group of calcium channel blockers (with amlodipine, isradipine and nifedipine) and is used primarily in the therapy of hypertension. Like other calcium channel blockers, felodipine acts by blocking the influx of calcium ions into vascular smooth muscle and cardiac muscle cells during depolarization, which results in arterial vasodilation and decrease in cardiac work and oxygen consumption. Felodipine was approved in the United States in 1991 and currently more than 3 million prescriptions are filled yearly. The current sole indication is treatment of hypertension, either alone or with other antihypertensive agents. Felodipine is available in multiple generic forms and under the commercial name Plendil in 2.5, 5 and 10 mg extended release tablets. The recommended dose in adults is 2.5 to 10 mg once daily, generally starting at the lowest dose and adjusting upward. Like other calcium channel blockers, felodipine is generally well tolerated, but side effects can include dizziness, flushing, headache, fatigue, nausea, diarrhea, peripheral edema, palpitations and rash.

### Hepatotoxicity, Outcome and Management

Felodipine therapy has been associated with low rates of serum enzyme elevations (<1% to 5%) which in many studies were no higher than occurred with placebo. ALT elevations were usually mild, asymptomatic and transient and often resolved even with continuation of therapy. Despite 20 years of clinical use, cases of clinically apparent liver injury due to felodipine have not been published. Thus, acute liver injury due to felodipine must be rare, if it occurs at all.

Likelihood score: E (Unlikely cause of clinically apparent liver injury).

Felodipine, however, can have significant drug-drug interactions. Felodipine is metabolized by the cytochrome P450 enzyme, CYP3A4, which is found in intestine and liver. Grapefruit juice can increases felodipine levels by inhibiting expression of intestinal CYP3A4 which ordinarily metabolizes it. Similarly, systemic drugs that inhibit CYP 3A4 (such as itraconazole or cimetidine) can increase and drugs that stimulate CYP 3A4 (such as phenytoin or phenobarbital) can lower felodipine levels significantly. Because felodipine can interact with other agents that are metabolized by the hepatic microsomal enzyme system, it may affect the risk of hepatotoxicity with other agents.

Drug Class: Cardiovascular Agents, Calcium Channel Blockers

Other Drugs in the Subclass, Calcium Channel Blockers: Amlodipine, Diltiazem, Isradipine, Nicardipine, Nifedipine, Nimodipine, Nisoldipine, Verapamil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Felodipine – Generic, Plendil®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=felodipine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Felodipine | 72509-76-3 | C18-H19-C12-N-O4 | Felodipine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 January 2017

Zimmerman HJ. Calcium channel blockers. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 646-7. (Expert review of hepatotoxicity published in 1999; among calcium channel blockers, only diltiazem, nifedipine, bepridil and verapamil have been incriminated in instances of hepatic injury; felopidine not mentioned).
De Marzio DH, Navarro VJ. Calcium channel blockers. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of calcium channel blockers; diliazem and verapamil have been implicated in causing cholestatic liver injury in a small number of patients; felodipine is not specifically mentioned).
Michel T, Hoffman BB. Calcium channel antagonists. Treatment of myocardial ischemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 755-60. (Textbook of pharmacology and therapeutics).
Edgar B, Lundborg P, Regardh CG. Clinical pharmacokinetics of felodipine. A summary. Drugs 1987; 34: (Suppl 3): 16-27. (Review of pharmacokinetics of felodipine; felodipine is highly protein bound and is extensively metabolized by the liver). 3327676
Lown KS, Bailey DG, Fontana RJ, Janardan SK, Adair CH, Fortlage LA, Brown MB, et al. Grapefruit juice increases felodipine oral availability in humans by decreasing intestinal CYP3A protein expression. J Clin Invest 1997; 99: 2545-53. (Pharmacokinetic study in 10 volunteers demonstrated downregulation of enterocyte CYP 3A4 by grapefruit juice and a three fold increase in bioavailability of felodipine). 9153299
Gradman AH, Cutler NR, Davis PJ, Robbins JA, Weiss RJ, Wood BC, Michelsen EL. Enalapril-Felodipine ER Factorial Study Group. Long-term efficacy, tolerability, and safety of the combination of enalapril and felodipine ER in the treatment of hypertension. Clin Ther 1998; 20: 527-38. (Among 507 patients treated with felodipine and enalapril for an average of 8 months, one patient stopped therapy because of a rise in ALT [from 72 to 93 U/L]). 9663368
McClennen W, Wilson T. National Trial Group. Felodipine extended release versus conventional diuretic therapy for the treatment of systolic hypertension in elderly patients. Clin Invest Med 1998; 21: 142-50. (Among 216 patients with hypertension treated with either felodipine or diuretics for 8 weeks, ALT or AST levels became elevated in 5-6% of felodipine- vs 1-2% of diuretic treated patients, but none required early discontinuation). 9627768
Black HR, Elliott WJ, Weber MA, Frishman WH, Strom JA, Liebson PR, Hwang CT, Ruff DA, Montoro R, DeQuattro V, Zhang D, Schleman MM, Klibaner MI. One-year study of felodipine or placebo for stage 1 isolated systolic hypertension. Hypertension 2001; 38: 1118-23. (In a controlled trial of felodipine vs placebo in 171 patients with hypertension, "there were no clinically meaninful changes from baseline" of ALT or AST). 11711508
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a calcium channel blocker). 15390328
Liu L, Zhang Y, Liu G, Li W, Zhang X, Zanchetti A. FEVER Study Group. The Felodipine Event Reduction (FEVER) Study: a randomized long-term placebo-controlled trial in Chinese hypertensive patients. J Hypertens 2005; 23: 2157-72. (A trial in 9800 patients treated with diuretics with or without felodipine for an average of 3 years reported no liver related adverse events). 16269957
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. PubMed Citation (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure; felodipine was possibly linked one case, but another hepatotoxic agent was being used [details not provided]).
Frishman WH, Hainer JW, Sugg J; M-FACT Study Group. A factorial study of combination hypertension treatment with metoprolol succinate extended release and felodipine extended release results of the Metoprolol Succinate-Felodipine Antihypertension Combination Trial (M-FACT). Am J Hypertens 2006; 19: 388-95. (In a controlled trial of multiple combinations of metoprolol and felodipine or placebo in 1092 patients with hypertension, no liver related side effects were reported). 16580575
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18955056) (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, calcium channel blockers were implicated as a sole agent in 2 cases [1 amlodipine, 1 verapamil] and as one of several agents in 2 cases [both amlodipine]).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to a calcium channel blocker). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which was attributed to a calcium channel blocker or other antihypertensive medication). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one case was attributed to verapamil, but none were linked to felodipine or other calcium channel blockers). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were due to antihypertensive agents including 4 due to calcium channel blockers [amlodipine in 1 and verapamil in 3 instances]). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Felodipine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=felodipine/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Felodipine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=felodipine)